# Benazepril

## OVERVIEW

### Introduction

Benazepril is an angiotensin-converting enzyme (ACE) inhibitor widely used in the therapy of hypertension. Benazepril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Benazepril (ben az' e pril) is an ACE inhibitor which is widely used in the therapy of hypertension. Like other ACE inhibitors, benazepril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other host enzymes besides that which converts angiotensin I to II may be inhibited as well, which may account for some of the side effects of the ACE inhibitors. Benazepril was approved for use in the United States in 1991 and current indications are for therapy of hypertension, either alone or in combination with other agents. Benazepril is available in 5, 10, 20 and 40 mg tablets in generic forms and under the trade name Lotensin. The typical dose in adults is 10 mg once daily initially, with gradual adjustment based upon blood pressure response and tolerance. The maximum daily dose is 40 mg in one or two divided doses administered long term. Benazepril is also available in fixed combinations with hydrochlorothiazide (Lotensin HCT and others) and with amlodipine (Lotrel and others). Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Benazepril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. A few rare instances of clinically apparent acute liver injury have been reported with benazepril therapy. In a single case report of severe liver injury leading to hepatic failure and death, the latency to onset was 14 months which resembles the rare instances of acute hepatocellular injury reported with captopril, enalapril and lisinopril. In contrast, typical ACE inhibitor related liver injury usually arises within 12 weeks of starting therapy and is associated with a cholestatic pattern of injury which can be severe and prolonged. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with benazepril is not known. The clinically apparent acute liver injury is likely an idiosyncratic reaction to a metabolite. Benazepril is hydrolyzed in the liver to the active metabolite benazeprilat.

### Outcome and Management

There have been too few instances of benazepril associated liver injury to provide an overall assessment of its course and outcome. Most instances of acute liver injury reported with ACE inhibitors have been self limited, but there have been rare reports of acute liver failure due to captopril, enalapril, lisinopril and benazepril and several reports of cholestatic hepatitis due to ACE inhibitors including benazepril leading to prolonged jaundice and vanishing bile duct syndrome. Patients with severe benazepril induced acute liver injury should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has not always been shown.

References to the safety and potential hepatotoxicity of benazepril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Benazepril – Generic, Lotensin®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Benazepril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Benazepril | 86541-75-5 | C24-H28-N2-O5 | Benazepril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Benazepril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Benazepril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Benazepril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Benazepril)